# Zidovudine

## OVERVIEW

### Introduction

Zidovudine is a nucleoside analogue and reverse transcriptase inhibitor used in combination with other agents in the therapy and prophylaxis of the human immunodeficiency virus (HIV) infection and the acquired immunodeficiency syndrome (AIDS). Zidovudine is a rare, but well established cause of clinically apparent acute and chronic liver injury.

### Background

Zidovudine (zye doe' vue deen) is a synthetic analogue of thymidine (3’-azido-3’- deoxythymidine: AZT) that is phosphorylated intracellularly and then acts in competing with the natural substrate, thymidine triphosphate, for incorporation into growing HIV DNA chain causing inhibition of the viral reverse transcriptase and chain termination. Zidovudine was the first antiretroviral agent that was approved for use in treating HIV infection in the United States [1987] and was subsequently frequently used in antiretroviral regimens for many years. Recently, zidovudine has been replaced by better tolerated nucleoside analogues and it is no longer commonly used in developed countries. Zidovudine is currently indicated for the treatment of HIV infection in combination with other HIV medications such as lamivudine and abacavir. Zidovudine is available as a single agent in multiple generic forms and under the trade name Retrovir in 100 mg capsules, 300 mg tablets, and as an oral syrup; in combination with lamivudine generically or as Combivir; and in combination with abacavir and lamivudine generically or as Trizivir. The recommended dose of zidovudine in adults is 300 mg orally twice daily or 1 mg/kg every 4 hours. Common side effects include asthenia, constipation, headache, insomnia, loss of appetite, malaise, nausea, and vomiting. Less common but potentially severe adverse events include lactic acidosis, pancreatitis, peripheral neuropathy, myopathy, anemia and neutropenia, and hypersensitivity reactions including Stevens Johnson syndrome.

### Hepatotoxicity

Chronic therapy with zidovudine is associated with modest serum enzyme elevations that are generally transient and asymptomatic and do not require dose modification. In prospective studies, 1 to 3% of recipients have developed ALT elevations above 5 times the upper limit of normal. The abnormalities, however, may be related to other underlying conditions such as hepatitis B or C and triggered by reconstitution syndrome.

Several forms of clinically apparent liver injury have been associated with zidovudine therapy: an acute cholestatic hepatitis, severe acute fatty liver and with lactic acidosis, and a chronic liver injury that presents with noncirrhotic portal hypertension, most likely due to nodular regenerative hyperplasia.

Rare instances of idiosyncratic cholestatic hepatitis have been reported with zidovudine therapy, typically arising within 1 to 4 weeks of starting treatment (Case 1). The liver injury is usually mild to moderate in severity and self-limited in course. Immunoallergic and autoimmune features are not common.

In addition, zidovudine has been associated with instances of severe hepatic steatosis and lactic acidosis. The liver injury typically arises after 2 to 6 months of therapy with prodromal symptoms of nausea, vomiting, anorexia and weakness, followed by dyspnea, jaundice and confusion. Lactic acid levels are elevated and metabolic acidosis may be severe and progressive. Serum enzymes are only modestly elevated and may initially be normal. Jaundice and signs of liver dysfunction develop late, but can eventually be associated with acute hepatic failure and death. Liver histology shows marked steatosis which is initially microvesicular and later macrovesicular and associated with cholestasis. In progressive cases, fibrosis and Mallory bodies are found. Similar cases occur with didanosine and stavudine which are more frequent causes of this syndrome. Risk factors for mitochondrial injury due to zidovudine include female sex, older age, preexisting liver disease, obesity, alcohol use and concurrent use of other di-deoxynucleosides.

Finally, long term therapy with zidovudine and other first generation nucleoside analogues has been associated with development of noncirrhotic portal hypertension. Symptoms are typically suggestive of cirrhosis, with fatigue, weight loss, ascites and/or variceal hemorrhage, but liver histology shows little or no fibrosis. Jaundice is uncommon. Laboratory testing demonstrates minor elevations in serum aminotransferase and alkaline phosphatase levels but normal levels of serum bilirubin, albumin and INR. Splenomegaly is common and thrombocytopenia is often the first manifestation of the hepatic abnormalities. Liver biopsies can be deceptively benign, with scant fibrosis and minor nonspecific changes. The disturbed hepatic architecture may not be obvious unless reticulum stains are done that show the typical nodularity and two-cell thick plates characteristic of nodular regeneration. The cause of nodular regenerative hyperplasia is not known but is suspected to be due to chronic vascular injury to the small veins and arterioles in portal areas.

Likelihood score: B (likely cause of clinically apparent acute and chronic liver disease).

### Mechanism of Injury

The cause of the microvesicular fat and hepatic failure with lactic acidosis appears to be due to inhibition of the mitochondrial gamma polymerase by zidovudine leading to mitochondrial depletion and dysfunction. Similar mitochondrial injury may occur in the pancreas causing pancreatitis, in muscle causing myopathy and in peripheral nerves causing neuropathy. The cause of other forms of clinically apparent liver injury due to zidovudine is unknown, but hypersensitivity may play a role. A similar mechanism may underlie the chronic liver injury from zidovudine which results in noncirrhotic portal hypertension. Genetic studies of children with inherited forms of noncirrhotic portal hypertension have shown homozygous mutations in genes involved with purine synthesis that are important in mitochondrial replication and integrity.

### Outcome and Management

The severity of liver injury caused by zidovudine ranges from mild and transient enzyme elevations to severe fatty liver, hepatic failure and lactic acidosis leading to death. In milder instances when the agent is withdrawn early, recovery occurs but is typically slow, requiring 1 to 3 months before return of liver enzymes and lactate levels to normal. Rechallenge may lead to recurrence and should be avoided. Patients should also avoid exposure to the other nucleoside analogues linked to this syndrome, particularly didanosine and stavudine. Various interventions have been used in attempts to treat the severe lactic acidosis and hepatic steatosis induced by nucleoside analogues. These interventions have included bicarbonate infusions, thiamine, l-carnitidine as well as renal dialysis and mechanical ventilation. Intravenous 20% glucose decreases lactic acid levels in some patients. Liver transplantation has reversed lactic acidosis in the rare patient that has undergone emergency transplantation, but this option is rarely practical.

Nodular regenerative hyperplasia is a long term complication of zidovudine therapy and generally improves once the agent is withdrawn and the patient switched to other antiretroviral agents. Therapy is generally directed at control of the complications of portal hypertension, including esophageal varices, ascites and hepatic encephalopathy. Patients with this complication should not receive first generation nucleoside analogues (didanosine, stavudine, zidovudine). Severe intercurrent medical conditions such as pneumonia or sepsis can cause worsening of the portal hypertension and signs and symptoms of hepatic decompensation (jaundice, worsening ascites, hepatic encephalopathy).

Drug Class: Antiviral Agents, Antiretroviral Agents

Other Drugs in the Subclass, Nucleoside Analogues: Abacavir, Adefovir, Didanosine, Emtricitabine, Entecavir, Lamivudine, Stavudine, Telbivudine, Tenofovir

## CASE REPORTS

### Case 1. Cholestatic hepatitis due to zidovudine.(1)

A 39 year old man with HIV and AIDS was started on zidovudine and developed fever and abdominal pain 5 days later. Serum enzymes were minimally elevated, but bilirubin was normal. Zidovudine was stopped, but he required hospitalization 6 days later because of worsening abdominal pain, jaundice and fever. At this point, serum bilirubin was 7.9 mg/dL and both ALT and alkaline phosphatase were several fold elevated (Table). Rash and eosinophilia were not mentioned. Ultrasound of the liver showed no evidence of biliary obstruction. Serum tests for hepatitis A and B were normal. He drank little alcohol and had no known exposures to hepatitis. He improved on no specific therapy and was discharged; liver tests abnormalities resolved within 4 weeks. He was then restarted on zidovudine at a reduced dose. Seven days later he redeveloped fever and abdominal pain and liver tests were again abnormal. Zidovudine was stopped and all abnormalities resolved within 4 weeks. He subsequently had no further evidence of liver disease, but died of AIDS-related complications approximately one-and-a-half years later.

#### Key Points

Medication: | Zidovudine (100 mg five times daily)
Pattern: | Cholestatic (R=0.7)
Severity: | 3+
Latency: | 5-6 days
Recovery: | 4 weeks
Other medications: | Trimethoprim-sulfamethoxazole, dicyclomine

#### Laboratory Values

Time After Starting | Time After Stopping | AST* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
Pre | Pre | 49 | 184 | 0.3
Zidovudine (200 mg every 6 hours) given for 7 days
7 days | 0 | 31 | 126 | 0.4
12 days | 6 days | 182 | 828 | 4.8
14 days | 8 days | 256 | 1587 | 5.7
16 days | 10 days | 238 | 1564 | 4.7
18 days | 12 days | 168 | 1173 | 1.0
24 days | 18 days | 70 | 782
4 weeks | 24 days | 38 | 368 | 0.7
5 weeks | 4 weeks | 28 | 288 | 0.5
Zidovudine (100 mg every 6 hours) restarted for 7 days
6 weeks | 0 | 88 | 633
7 weeks | 1 week | 42 | 380 | 0.4
12 weeks | 5 weeks | 24 | 126 | 0.3
Normal Values | | <35 | <115 | <1.2

* Estimated from Figure and converted from times upper limit of normal to specific values based upon normal values shown.

#### Comment

Case of cholestatic hepatitis with short latency (<1 week) induced by zidovudine. The injury had a prodrome of fever and abdominal pain arising after 5 days of therapy that preceded the elevations in liver enzymes and serum bilirubin. Jaundice arose several days after zidovudine was stopped, serum bilirubin peaking 1 week later. The article did not mention skin rash, lymphadenopathy, lymphocytosis or eosinophilia, but the abrupt onset and presence of fever suggested an immunoallergic cause. The recurrence of cholestatic liver enzyme elevations on reexposure to zidovudine strengthened the association of the liver injury with this drug. The importance of zidovudine in therapy of HIV infection at the time of this clinical report justified the rechallenge effort to exonerate zidovudine as the cause of the liver injury.

### Case 2. Lactic acidosis with severe hepatic steatosis due to zidovudine therapy.(2)

A 48 year old man with HIV and AIDS on long term zidovudine therapy developed nausea, abdominal pain and dyspnea. He had severe lactic acidosis with a bicarbonate level of 5 mg/dL, and serum lactate of 20.2 mmol/L (normal <3.0). Liver tests showed ALT 109 U/L and alkaline phosphatase of 207 U/L. His liver tests had previously been normal. He tested negative for serological evidence of hepatitis B or C. Other medications which he had been taking chronically included ranitidine and trimethoprim-sulfamethoxazole. After admission, he worsened rapidly with progressive obtundation, respiratory failure and intractable metabolic acidosis. An autopsy showed a massive liver (3.7 kg) with both macro- and microvesicular fatty change.

#### Key Points

Medication: | Zidovudine
Pattern: | Mild elevations only
Severity: | 5+ (fatal lactic acidosis and hepatic failure)
Latency: | Several years
Recovery: | None
Other medications: | Trimethoprim-sulfamethoxazole, ranitidine

#### Comment

Severe but typical course of lactic acidosis with microvesicular fatty liver that can occur with nucleoside analogue therapy. Despite the severity of the liver involvement, serum enzyme elevations may be normal or only modestly elevated. Initial signs of hepatic synthetic failure may be fall of albumin or rising prothrombin time and hepatic encephalopathy. Frequently, as in this case, lactic acidosis is the major clinical problem and cause of multiorgan failure. Pancreatitis can also complicate the course of nucleoside analogue induced mitochondrial injury and may be the immediate cause of death. The underlying pathogenesis of this form of hepatotoxicity appears to be mitochondrial injury or depletion caused by inhibition of the mitochondrial gamma polymerase which is responsible for replication of mitochondria DNA. Different nucleoside analogues have different degrees of likelihood of causing mitochondrial toxicity: fialuridine >> stavudine, zalcitabine and didanosine > zidovudine >> lamivudine, abacavir, emtricitabine, telbivudine, tenofovir, adefovir and entecavir (the last group may not cause this syndrome at all). In addition, different nucleoside analogues appear to cause different degrees of mitochondrial injury in different tissues. Thus, myopathy and neuropathy are most frequent with zidovudine, pancreatitis with didanosine and stavudine, and lactic acidosis with microvesicular fatty liver with fialuridine.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Zidovudine – Generic, Retrovir®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=zidovudine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Zidovudine | 30516-87-1 | C10-H13-N5-O4

## CITED REFERENCES

1 Dubin G, Braffman MN. (1989). Zidovudine-induced hepatotoxicity. Ann Intern Med.
2 Fortgang IS, Belitsos PC, Chaisson RE, Moore RD. (1995). Hepatomegaly and steatosis in HIV-infected patients receiving nucleoside analog antiretroviral therapy. Am J Gastroenterol.

## ANNOTATED BIBLIOGRAPHY

References updated: 25 June 2020

Abbreviations used: AIDS, acquired immune deficiency syndrome; HBV, hepatitis B virus; HCV, hepatitis C virus; HIV, human immunodeficiency virus; HPA, hepatoportal sclerosis; HVPG, hepatic venous pressure gradient; mt, mitochondrial; NASH, nonalcoholic steatohepatitis; NCPH, noncirrhotic portal hypertension; NRH, nodular regenerative hyperplasia; TE, transient elastography.

Núñez M. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 505-18. (Review of hepatotoxicity of antiviral agents including zidovudine).
Flexner C. Antiretroviral agents and treatment of HIV infection. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1137-58. (Textbook of pharmacology and therapeutics).
National Institutes of Health. http://aidsinfo.nih.gov/guidelines. (Clinical guidelines on the use of antiretroviral agents in HIV-1 infected adults, adolescents and children).
Richman DD, Fischl MA, Grieco MH, Gottlieb MS, Volberding PA, Laskin OL, Leedom JM, et al. (1987). The toxicity of azidothymidine (AZT) in the treatment of patients with AIDS and AIDS-related complex. A double-blind, placebo-controlled trial. N Engl J Med. (Controlled trial in 282 patients with AIDs reported that rates of serum enzyme elevations were similar in placebo as zidovudine-treated patients).
Melamed AJ, Muller RJ, Gold JW, Campbell SW, Kleinberg MI, Armstrong D. (1987). Possible zidovudine-induced hepatotoxicity. JAMA. (3 of 28 patients with HIV infection developed liver test abnormalities 2-3 weeks after starting zidovudine [AST of 161, 196 and 684 U/L, Alk P of 112 and 351 U/L], resolving rapidly with stopping and not recurring with reexposure: no mention of bilirubin or symptoms).
Dubin G, Braffman MN. (1989). Zidovudine-induced hepatotoxicity. Ann Intern Med. (39 year old man with HIV and AIDS developed fever and abdominal pain 7 days after starting zidovudine [bilirubin 6.5 mg/dL, ALT 122 U/L, Alk P 598 U/L], resolving rapidly with stopping and recurring within 7 days upon restarting: Case 1).
Jolliet P, Widman JJ. (1990). Reye’s syndrome in adult with AIDS. Lancet. (26 year old woman with HIV infection on zidovudine for 1 year developed fever and cough and was given aspirin [3 g/day], developed lethargy and abnormal liver tests 12 days later with progressive liver failure and death; macrovesicular fat considered typical of Reyes syndrome found on liver biopsy).
Hochster H, Dieterich D, Bozzette S, Reichman RC, Connor JD, Liebes L, Sonke RL, et al. (1990). Toxicity of combined ganciclovir and zidovudine for cytomegalovirus disease associated with AIDS. An AIDS Clinical Trials Group Study. Ann Intern Med. (40 patients with HIV and CMV infection were treated with zidovudine and intravenous ganciclovir; anemia and neutropenia were common; 1 patient developed hepatitis thought to be zidovudine related, resolving on stopping and recurring on restarting zidovudine [timing and details not given]).
Kahn JO, Lagakos SW, Richman DD, Cross A, Pettinelli C, Liou S-H, Broom M, et al. (1992). A controlled trial comparing continued zidovudine with didanosine in human immunodeficiency virus infection. N Engl J Med. (913 patients with HIV infection on zidovudine were randomized to switch to didanosine [500 or 750 mg/day] or continue zidovudine; pancreatitis occurred in 7% and 13% of didanosine, but only 3% of zidovudine-treated patients; no mention of ALT levels of hepatotoxicity).
Division of AIDS, National Institute of Allergy and Infectious Diseases. Table for grading severity of adult adverse experiences. Version 1.0, Clarification August 2009. Website accessed November 2011. http://www.docstoc.com/docs/42821660/DAIDS-Toxicity-Table. (Tables for grading ALT, AST, Alk P and bilirubin elevations for the AIDS Clinical Trials Group, all expressed as upper limits of normal [ULN]; for ALT, AST, Alk P and GGT: grade 1 [mild]=1.25-2.5; grade 2 [moderate]=2.6-5.0; grade 3 [severe]=5.1-10.0; and grade 4 [potentially life-threatening]=>10.0 times ULN).
Chen SC, Barker SM, Mitchell DH, Stevens SM, O’Neill P, Cunningham AL. (1992). Concurrent zidovudine-induced myopathy and hepatotoxicity in patients treated for human immunodeficiency virus(HIV) infection. Pathology. (38 year old man with AIDS on zidovudine for 4 months developed muscle and abdominal pain [bilirubin 0.8 mg/dL, ALT, 115 U/L, Alk P 62 U/L, CPK 1926 U/L], liver biopsy showing macrovesicular steatosis and abnormalities, resolving within 3 months of stopping).
Gradon JD, Chapnik EK, Sepkowitz DV. (1992). Zidovudine-induced hepatitis. J Intern Med. (38 year old man developed tender hepatomegaly 3 months after starting zidovudine and dapsone [bilirubin 2.0 mg/dL, ALT 120 U/L, Alk P 104 U/L], worsening in next 4 weeks despite stopping dapsone [bilirubin 9.7 mg/dL, ALT 873 U/L], but rapidly resolving within 10 days of stopping zidovudine).
Shriner K, Goetz M. (1992). Severe hepatotoxicity in a patient receiving both acetaminophen and zidovudine. Am J Med. (31 year old man with AIDS, malnutrition and pancreatitis on long term zidovudine and TMP/SMS developed fever, rash, cellulitis and marked ALT elevations 3 days after starting iv cephalothin and receiving 3.3 g of acetaminophen [bilirubin 1.2 mg/dL], resolving rapidly upon stopping, but role of zidovudine unlikely).
Chattha G, Arieff AI, Cumings G, Tierney LM. (1993). Lactic acidosis complicating the acquired immunodeficiency syndrome. Ann Intern Med. (Report of 7 patients with HIV infection who developed lactic acidosis of unknown cause who presented with nausea, anorexia and weight loss followed by dyspnea, stupor and death [in 4]; 4 on zidovudine, 1 ganciclovir and 1 clofazimine; initial arterial pH 7.09-7.27, lactate 10.4-17.4 mmol/L).
Shintaku M, Nasu K, Shimizu T. (1993). Fulminant hepatic failure in an AIDS patient: possible zidovudine-induced hepatotoxicity. Am J Gastroenterol. (38 year old man with hemophilia and HIV-HBV coinfection developed jaundice within 3 weeks of starting zidovudine [bilirubin 6.0 mg/dL, ALT 2,267 U/L], progressing to hepatic failure and death, with autopsy showing massive necrosis and cirrhosis; cause unclear, but possibly due to immune reconstitution and acute reactivation of hepatitis B).
Freiman JP, Helfert KE, Hammrell MR, Stein DS. (1993). Hepatomegaly with severe steatosis in HIV-seropositive patients. AIDS. (8 patients with HIV who developed severe hepatomegaly and marked steatosis which was associated with hepatic failure and lactic acidosis, 6 being fatal and 2 with recovery; all had received zidovudine, but for varying periods and often stopped well before onset of symptoms from hepatotoxicity).
Le Bras P, D’Oiron R, Quertainmont Y, Halfon P, Caquet R. (1994). Metabolic, hepatic and muscular changes during zidovudine therapy: a drug-induced mitochondrial disease?. AIDS. (32 year old man with hemophilia and HIV infection developed severe myopathy and fatty liver 8 months after starting zidovudine [CPK 1138 U/L and mild lactic acidosis], resolving with stopping drug).
McKenzie R, Fried MW, Sallie R, Conjeevaram H, Di Bisceglie AM, Park Y, Savarese B, et al. (1995). Hepatic failure and lactic acidosis due to fialuridine (FIAU), an investigational nucleoside analogue for chronic hepatitis B. N Engl J Med. (Description of syndrome of lactic acidosis, hepatic failure and pancreatitis arising after 8-11 weeks of fialuridine treatment in 15 patients with chronic hepatitis B; among 7 patients affected, 5 died of intractable lactic acidosis and 2 survived but required emergency liver transplantation).
Lewis W, Dalakas MC. (1995). Mitochondrial toxicity of antiviral drugs. Nat Med. (Review of mechanisms for mitochondrial injury by nucleoside analogues including inhibition of mitochondrial DNA polymerase gamma).
Styrt B, Freiman JP. (1995). Hepatotoxicity of antiviral agents. Gastroenterol Clin North Am. (Early review of liver toxicity of antiviral agents; covering the first four nucleoside analogues used for HIV infection, zidovudine, didanosine, zalcitabine and stavudine).
Wassef M, Keiser P. (1995). Hypersensitivity to zidovudine: report of a case of anaphylaxis and review of the literature. Clin Infect Dis. (41 year old man with HIV infection, developed weakness and confusion 1 hour after a second dose of zidovudine with erythema, facial swelling and fever [ALT 157 U/L], resolving within 48 hours of stopping and recurring within 1 hour of single dose rechallenge with zidovudine; no mention of jaundice).
Fortgang IS, Belitsos PC, Chaisson RE, Moore RD. (1995). Hepatomegaly and steatosis in HIV-infected patients receiving nucleoside analog antiretroviral therapy. Am J Gastroenterol. (Retrospective review of 1836 patients treated for HIV infection found 322 [18%] with liver abnormalities and two [1.3 per 1000 person-years] with fatal lactic acidosis and fatty liver, both on zidovudine only).
Olano JP, Borucki MJ, Wen JW, Haque AK. (1995). Massive hepatic steatosis and lactic acidosis in a patient with AIDS who was receiving zidovudine. Clin Infect Dis. (35 year old woman developed nausea, vomiting and weakness 5 months after starting zidovudine [bilirubin 0.9 mg/dL, ALT 85 U/L, Alk P 85 U/L], worsening over next week with severe lactic acidosis and pancreatitis despite stopping zidovudine promptly; autopsy showed massively enlarged liver [3.6 kg] with marked steatosis, but little inflammation or necrosis).
Aggarwal A, al Talib K, Alabrash M. (1996). Type B lactic acidosis in an AIDS patient treated with zidovudine. Md Med J. (33 year old woman with HIV infection developed anorexia, weight loss, and tachypnea 9 months after starting zidovudine [lactate 16.3 mmol/L, pH 7.3 falling to 7.0, CT showing fatty liver, enzymes and bilirubin not given], dying of progressive lactic acidosis 3 days later).
Henry K, Acosta EP, Jochimsen E. (1996). Hepatotoxicity and rash associated with zidovudine and zalcitabine chemoprophylaxis. Ann Intern Med. (Two nurses receiving zidovudine and zalcitabine for prevention of HIV infection after accidental needlestick for 3 weeks had fever, rash and nausea and liver test abnormalities, resolving rapidly with stopping drugs).
Charton-Bain MC, Flamant M, Aubertin JM, Belair MF, Gilquin J, Kazatchkine M, Bruneval P. (1997). Gastroenterol Clin Biol. (33 year old man with HIV infection developed lactic acidosis 8 months after starting zidovudine [pH 7.25, lactate 8 mmol/L, ALT and Alk P normal], with biopsy showing marked steatosis and abnormal mitochondria).
Sundar K, Suarez M, Banogon PE, Shapiro JM. (1997). Zidovudine-induced fatal lactic acidosis and hepatic failure in patients with acquired immunodeficiency syndrome: report of two patients and review of the literature. Crit Care Med. (47 year old man and 57 year old woman with HIV infection presented with weakness and fatigue 6 and 9 months after starting zidovudine [bilirubin 2.7 and 0.8 mg/dL, ALT 85 and 109 U/L and Alk P 59 U/L], with progressive lactic acidosis and death; autopsy showed extensive hepatic steatosis).
Brinkman K, ter Hofstede HJ, Burger DM, Smeitink JAM, Koopmans PP. (1998). Adverse effects of reverse transcriptase inhibitors: mitochondrial toxicity as a common pathway. AIDS. (Review of mitochondrial function and role of mitochondrial toxicity or depletion in the adverse side effects of nucleoside analogues).
Blanche S, Rustin P, Slama A, Barret B, Firtion G, Ciraru-Vigneron N, Lacrois C, et al. (1999). Persistent mitochondrial dysfunction and perinatal exposure to antiretroviral nucleoside analogues. Lancet. (Screening for mitochondrial symptoms among children born to HIV-positive mothers treated with zidovudine during pregnancy identified 6 with mitochondrial dysfunction, ages a few months to 4 years, hyperlactatemia in 5, liver enzyme elevations in 3, hyperamylasemia in 2).
Acosta BS, Grimsley EW. (1999). Zidovudine-associated type B lactic acidosis and hepatic steatosis in an HIV-infected patient. South Med J. (34 year old woman with HIV infection developed nausea and weakness 1 year after starting zidovudine, with severe lactic acidosis but normal liver tests initially, progression to multiorgan failure and death, autopsy showed massive hepatomegaly and steatosis).
Chariot P, Drogou I, de Lacroix-Szmania I, Eliezer-Vanerot M, Chazaud B, Lombès A, Schaeffer A, et al. (1999). Zidovudine-induced mitochondrial disorder with massive liver steatosis, myopathy, lactic acidosis, and mitochondrial DNA depletion. J Hepatol. (57 year old man with HIV infection developed nausea and fatigue with progressive lactic acidosis and death 6 months after starting a second course of zidovudine [bilirubin normal, ALT 8 times ULN, Alk P normal], autopsy showing massive micro- and macro-steatosis).
Sulkowski MS, Thomas DL, Chaisson RE, Moore RD. (2000). Hepatotoxicity associated with antiretroviral therapy in adults infected with human immunodeficiency virus and the role of hepatitis C or B virus infection. JAMA. (Among 298 patients with HIV infection, ALT elevations above 5 times ULN occurred in 10.4% per year during antiretroviral treatment; factors associated with ALT elevations included ritonavir [27.3%] and coinfection with either HCV or HBV; ALT with bilirubin elevations occurred in 3 patients; 2 on indinavir and all 3 with coinfection).
Velasco M, Guijarro C. (2000). Elevated liver enzymes following initiation of antiretroviral therapy. JAMA. (Letter in response to Sulkowski et al. [JAMA 2000] pointing out that antiretroviral therapy can cause immune reconstitution and flares of hepatitis B or C, which may be misdiagnosed as hepatotoxicity).
Sulkowski MS, Thomas DL, Chaisson RE, Moore RD. (2000). Elevated liver enzymes following initiation of antiretroviral therapy. JAMA. (Reply to Velasco and Guijarro pointing at that the majority of the ALT elevations described could not be attributed to immune reconstitution).
Pai VB, Koranyi K, Nahata MC. (2000). Acute hepatitis and bleeding possibly induced by zidovudine and ritonavir in an infant with HIV infection. Pharmacotherapy. (9 year old boy with HIV infection and multiple complications developed fever, thrombocytopenia and hepatitis 2 months after starting zidovudine, lamivudine and ritonavir, with progressive liver failure and severe bleeding after liver biopsy; difficult to assign specific causality to a specific agent).
Hill JB, Sheffield JS, Zeeman GG, Wendel GD. (2001). Hepatotoxicity with antiretroviral treatment of pregnant women. Obstet Gynecol. (Two cases, 28 year old woman on zidovudine, lamivudine and efavirenz developed jaundice at 18 weeks gestation [bilirubin 20.3 mg/dL, ALT 421 U/L], remaining jaundiced until delivered at 27 weeks, resolving within 5 months after delivery; 22 year old woman started on lamivudine, zidovudine and nelfinavir at 14 weeks gestation and developed jaundice 10 weeks later [bilirubin 8.9 mg/dL, ALT 1598 U/L], progressing to acute liver failure and death).
John M, Moore CB, James IR, Nolan D, Upton RP, McKinnon EJ, Mallal SA. (2001). Chronic hyperlactatemia in HIV-infected patients taking antiretroviral therapy. AIDS. (349 patients with HIV infection were screened for lactate levels on multiple occasions; 2 had lactic acidosis and both were symptomatic and on stavudine: estimated incidence of 3.9 per 1000 person years).
Church JA, Mitchell WG, Gonzalez-Gomez I, Christensen J, Vu TH, Dimauro S, Boles RG. (2001). Mitochondrial DNA depletion, near-fatal metabolic acidosis, and liver failure in an HIV-infected child treated with combination antiretroviral therapy. J Pediatr. (2 year old boy treated for 18 months with didanosine, zidovudine and nelfinavir developed lactic acidosis and hepatic failure [bilirubin 30.6 mg/dL, AST 224 U/L], resolving slowly with stopping drugs).
Coghlan ME, Sommadossi JP, Jhala NC, Many WJ, Saag MS, Johnson VA. (2001). Symptomatic lactic acidosis in hospitalized antiretroviral-treated patients with human immunodeficiency virus infection: a report of 12 cases. Clin Infect Dis. (Experience with 12 cases of lactic acidosis in patients with HIV infection seen over 6 years, typically with anorexia, nausea and weight loss for several weeks, AST variably elevated, 11 on stavudine, 9 didanosine, 1 zidovudine alone; 6 with pancreatitis, 6 having liver biopsies all showed macro- and micro-steatosis; five died).
Clark SJ, Creighton S, Portmann B, Taylor C, Wendon JA, Cramp ME. (2002). Acute liver failure associated with antiretroviral treatment for HIV: a report of six cases. J Hepatol. (6 patients with HIV infection who developed acute liver failure on stavudine [n=5], lamivudine [n=3], didanosine [n=2], saquinavir [n=2], efavirenz [n=2], nevirapine [n=2], or nelfinavir, delavirdine or zidovudine [n=1] for 1-3 months [peak bilirubin 2.7-32 mg/dL, AST 240-8650 U/L, Alk P 122-191 U/L]; 2 with signs of hypersensitivity; two with hepatitis B; 5 died, autopsies showing massive necrosis; one with massive steatosis; likely multiple causes).
Hillaire S, Bonte E, Denninger MH, Casadevall N, Cadranel JF, Lebrec D, Valla D, et al. (2002). Idiopathic non-cirrhotic intrahepatic portal hypertension in the West: a re-evaluation in 28 patients. Gut. (Among 28 cases of NCPH diagnosed between 1994 and 1998, none were diagnosed with HIV infection and no discussion of drug relatedness; 12 had a prothrombotic disorder).
Falcó V, Rodríguez D, Ribera E, Martínez E, Miró JM, Domingo P, Diazaraque R, et al. (2002). Severe nucleoside-associated lactic acidosis in human immunodeficiency virus-infected patients: report of 12 cases and review of the literature. Clin Infect Dis. (Between 1997-2000, 12 cases of lactic acidosis in HIV-infected patients identified at 4 hospitals in Spain; ~1:1000 patient-years of treatment; all were receiving nucleoside analogues for 1-36 months; 1 case attributed to zidovudine, 11 to stavudine [1 also on didanosine], ALT 30-524 U/L, 33% fatality rate).
Spengler U, Lichterfeld M, Rockstroh JK. (2002). Antiretroviral drug toxicity—a challenge for the hepatologist?. J Hepatol. (Review of the diagnosis of drug induced liver disease in patients with HIV on antiretroviral agents, with discussion of mechanisms including mitochondrial toxicity and hypersensitivity reactions).
Koch RO, Graziadei IW, Zangerle R, Romani N, Maier H, Vogel W. (2003). Acute hepatic failure and lactate acidosis associated with antiretroviral treatment for HIV. Wien Klin Wochenschr. (HIV-positive woman taking stavudine and didanosine for 18 months developed lactic acidosis with renal and hepatic failure, but recovered with stopping agents; liver biopsy showed microvesicular steatosis and giant mitochondria).
Bonnet F, Bonarek M, Morlat P, Mercie P, Dupon M, Gemain MC, Malvy D, et al. (2003). Risk factors for lactic acidosis in HIV-1-infected patients treated with nucleoside reverse-transcriptase inhibitors: a case-control study. Clin Infect Dis. (Case control study of 9 patients [5 women] with HIV infection and lactic acidosis, 6 with hepatomegaly, 5 with jaundice, 8 on stavudine, 7 on didanosine, 6 on zidovudine; 6 died; risk factors were renal insufficiency and low CD4 counts, but numbers of cases were few).
Arenas-Pinto A, Grant AD, Edwards S, Weller IVD. (2003). Lactic acidosis in HIV-1 infected patients: a systematic review of published cases. Sex Transm Infect. (Review of 217 published cases of lactic acidosis; 53% female, all were taking at least one nucleoside for 1-36 months, 61% on stavudine, 33% didanosine, 31% zidovudine, 30% lamivudine; 92% had hepatic steatosis on biopsy or autopsy; 48% died).
Lonergan JT, Barber RE, Mathews WC. (2003). Safety and efficacy of switching to alternative nucleoside analogues following symptomatic hyperlactatemia and lactic acidosis. AIDS. (12 patients with HIV infection on antiretrovirals who developed hyperlactatemia >5 mmol/L [2 with acidosis; all on stavudine] stopped therapy and improved, restarting nucleosides without stavudine was tolerated in all but one case [on zidovudine], who later tolerated lamivudine and abacavir).
Kontorinis N, Dieterich D. (2003). Hepatotoxicity of antiretroviral therapy. AIDS Rev. (Review of hepatotoxicity of antiretroviral drugs; definition of hepatotoxicity in antiretroviral studies; grade 1=1.25-2.5 times, grade 2=2.6-5 times, grade 3=5.1-10 times and grade 4=>10 times ULN or baseline ALT values; abacavir and lamivudine are least likely to cause hepatotoxicity).
Ogedegbe AE, Thomas DL, Diehl AM. (2003). Hyperlactataemia syndromes associated with HIV therapy. Lancet Infect Dis. (Review of mechanisms of hyperlactatemia with antiretroviral therapy, occurs mostly with use of nucleoside analogues, stavudine, didanosine and zidovudine, attributed to mitochondrial depletion, but other mechanisms may be involved).
Ofotokun I, Pomeroy C. (2003). Sex differences in adverse reactions to antiretroviral drugs. Top HIV Med. (Review of sex differences in adverse events; higher frequency of mitochondrial toxicity and hypersensitivity in women than men).
Ogedegbe AO, Sulkowski MS. (2003). Antiretroviral-associated liver injury. Clin Liver Dis. (Review of hepatotoxicity of antiretrovirals; ALT elevations above 5 times ULN reported in 7% with zidovudine, 16% didanosine, 9-13% stavudine, <1% lamivudine, tenofovir and abacavir, 3-10% protease inhibitors, 10% nevirapine and 8% efavirenz; recommend monitoring at 4 weeks and then every 12 weeks, stopping if ALT levels are >10 times ULN or if symptoms of liver injury are present, monitoring more closely if ALT levels are elevated).
Abrescia N, D’Abbraccio M, Figoni M, Busto A, Maddaloni A, De Marco M. (2005). Hepatotoxicity of antiretroviral drugs. Curr Pharm Des. (Review of hepatotoxicity of antiretrovirals; major syndrome with nucleoside analogues is mitochondrial injury with lactic acidosis and severe hepatomegaly and steatosis).
Jain MK. (2007). Drug-induced liver injury associated with HIV medications. Clin Liver Dis. (Review of hepatotoxicity of antiretroviral medications; ALT elevations occur in 2-18% of patients, but often resolve spontaneously even without dose modification; classes of injury include hypersensitivity [nevirapine, efavirenz, abacavir], mitochondrial injury [stavudine, didanosine, zidovudine], flares of hepatitis B [lamivudine, emtricitabine, tenofovir], flares of hepatitis C [any potent regimen], idiosyncratic injury [ritonavir, nevirapine, efavirenz], cholestatic hepatitis [many agents]).
Wester CW, Okezie OA, Thomas AM, Bussmann H, Moyo S, Muzenda T, Makhema J, et al. (2007). Higher-than-expected rates of lactic acidosis among highly active antiretroviral therapy-treated women in Botswana: preliminary results from a large randomized clinical trial. J Acquir Immune Defic Syndr. (Among 650 patients starting antiretroviral therapy, 2% developed hyperlactaemia [>4.4 mmol/L] and 1% lactic acidosis [all female, trend towards older age and higher body mass index] all on stavudine, didanosine, and/or zidovudine; 6 died, 4 of pancreatitis).
Bolhaar MG, Karstaedt AS. (2007). A high incidence of lactic acidosis and symptomatic hyperlactatemia in women receiving highly active antiretroviral therapy in Soweto, South Africa. Clin Infect Dis. (Among 1735 adults with HIV infection started on antiretroviral therapy, 3% developed hyperlactatemia; 23 [1%] with lactic acidosis [22 women and 22 on stavudine, 1 on didanosine and zidovudine], 30% mortality; 44 had symptomatic hyperlactatemia [37 women, all 44 on stavudine, 3 also with didanosine], able to switch to zidovudine without recurrence, 2 of 3 relapsed on restarting stavudine).
Lactic Acidosis International Study Group. (2007). Risk factors for lactic acidosis and severe hyperlactataemia in HIV-1-infected adults exposed to antiretroviral therapy. AIDS. (Retrospective case control study of 110 cases with hyperlactataemia vs 220 controls, identified risk factors of older age, female gender, low CD4 counts, and use of stavudine, didanosine or both).
Mallet V, Blanchard P, Verkarre V, Vallet-Pichard A, Fontaine H, Lascoux-Combe C, Pol S. (2007). Nodular regenerative hyperplasia is a new cause of chronic liver disease in HIV-infected patients. AIDS. (Among 8 patients with HIV infection referred for evaluation of liver disease of unknown cause, all had nodular regenerative hyperplasia and had received didanosine [and many received stavudine or zidovudine] for 1 to 2 years [bilirubin 0.2-2.0 mg/dL, ALT 0.4-2.0 times ULN, Alk P 0.9-19.1 times ULN, platelets 71-149,000/μL], all had varices and 5 had ascites).
Castelnuovo B, Nanyonjo A, Kamya M, Ocama P. (2008). Is it safe to switch from stavudine to zidovudine after developing symptomatic hyperlactatemia?. Afr Health Sci. (60 year old woman developed symptomatic lactatemia 19 months after starting stavudine, lamivudine and nevirapine; switching to zidovudine was followed by fall of lactate levels to normal [5.2→1.6 mmol/L], but 10 months later levels rose again [3.7 mmol/L]).
Stead D, Osler M, Boulle A, Rebe K, Meintjes G. (2008). Severe hyperlactataemia complicating stavudine first-line antiretroviral therapy in South Africa. Antivir Ther. (Retrospective analysis of 75 patients with HIV infection and symptomatic hyperlactatemia; 95% women, all on stavudine [1.7 per 100 patient-years], 71% with lactic acidosis, 12 died; 30 switched to zidovudine without recurrence).
Hammer SM, Eron JJ, Reiss P, Schooley RT, Thompson MA, Walmsley S, Cahn P, et al., International AIDS Society-USA. (2008). Antiretroviral treatment of adult HIV infection: 2008 recommendations of the International AIDS Society-USA panel. JAMA. (Most recent recommendations on use of antiviral therapy in adults with HIV infection including use of recently approved agents, raltegravir, maraviroc and etravirine).
Inductivo-Yu I, Bonacini M. (2008). Highly active antiretroviral therapy-induced liver injury. Current Drug Safety. (Review of drug induced liver injury due to antiretroviral agents).
Soriano V, Puoti M, Garcia-Gascó P, Rockstroh JK, Benhamou Y, Barreiro P, McGovern B. (2008). Antiretroviral drugs and liver injury. AIDS. (Review of hepatotoxicity of antiretroviral drugs with recommendations on management, stopping therapy if symptoms arise, with overt jaundice [direct bilirubin], evidence of mitochondrial toxicity, ALT >10 times ULN, ALT at lower levels if newly marketed agent; important to rule out other causes; problematic agents include didanosine, stavudine and zidovudine, nevirapine and efavirenz, full dose ritonavir and tipranavir).
Bae WH, Wester C, Smeaton LM, Shapiro RL, Lockman S, Onyait K, Thior I, et al. (2008). Hematologic and hepatic toxicities associated with antenatal and postnatal exposure to maternal highly active antiretroviral therapy among infants. AIDS. (Prospective monitoring found that only 1 of 69 infants born to antiretroviral treated mothers and none of 109 infants born to drug-therapy unexposed mothers with HIV infection developed ALT elevations >5 times ULN during the first 7 months of life).
Kumarasamy N, Venkatesh KK, Cecelia AJ, Devaleenal B, Lai AR, Saghayam S, Balakrishnan P, Yepthomi T, Poongulali S, Flanigan TP, Solomon S, Mayer KH. (2008). Spectrum of adverse events after generic HAART in southern Indian HIV-infected patients. AIDS Patient Care STDS. (Among 3154 patients with HIV infection treated with antiretroviral agents over a 4 year period at a single center in Southern India, hepatitis occurred in 3.5% usually within the first 3 months; lactic acidosis was more common in women and was associated with stavudine use).
Van Dyke RB, Wang L, Williams PL. (2008). Pediatric AIDS Clinical Trials Group 219C Team. Toxicities associated with dual nucleoside reverse-transcriptase inhibitor regimens in HIV-infected children. J Infect Dis. (Among 2233 children receiving two nucleoside reverse-transcriptase inhibitors, 0.6-1.6% developed hepatitis, 8.3-13.5% acidosis; overall ALT elevations were rare [<1%]).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 7 were attributed to antiretroviral agents, 2 nevirapine, 1 efavirenz and 4 miscellaneous combinations).
Ingiliz P, Benhamou Y. (2009). Elevated liver enzymes in HIV monoinfected patients on HIV therapy: what are the implications?. J HIV Ther. (Review of the causes of serum enzyme elevations during antiretroviral therapy; nucleoside reverse transcriptase inhibitors are capable of causing lactic acidosis, most commonly with zalcitabine, didanosine, stavudine and zidovudine; abacavir has been linked to hypersensitivity reactions and rare instances of hepatic failure).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, 3 antiretroviral agents were among the top 40 cases, including zidovudine [8th, 106 cases], lamivudine [26th, 45 cases] and nevirapine [36th, 37 cases]).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury and 4 to antiretroviral agents, including 3 to combinations with stavudine and 1 to abacavir).
Schiano TD, Uriel A, Dieterich DT, Fiel MI. (2011). The development of hepatoportal sclerosis and portal hypertension due to didanosine use in HIV. Virchows Arch. (45 year old man with HIV infection developed abnormal liver tests 4 years after starting didanosine [bilirubin normal, ALT 87 U/L, Alk P 286 U/L], biopsy showing nodular regeneration which progressed despite stopping and 5 years later he presented with varices and hepatomegaly [bilirubin 1.0 mg/dL, ALT 43 U/L, Alk P 166 U/L, platelets 104,000/μL]).
Lopez-Delgado JC, Mendiluce RM, Pinol TS, Fernández XP, Sanchez L, Vicente RG. (2012). Urgent liver transplantation for nevirapine-induced acute liver failure: report of a case and review of the literature. Ann Transplant. (40 year old woman developed fever and jaundice 4 weeks after switching nevirapine for lopinavir/ritonavir in a antiretroviral regimen [bilirubin 5.0 mg/dL, ALT 5200 U/L, GGT 258 U/L, INR 4.5], with progressive hepatic failure and successful liver transplant 3 days later).
Nielsen-Saines K, Watts DH, Veloso VG, Bryson YJ, Joao EC, Pilotto JH, Gray G, et al. (2012). NICHD HPTN 040/PACTG 1043 Protocol Team. Three postpartum antiretroviral regimens to prevent intrapartum HIV infection. N Engl J Med. (Controlled trial of 3 zidovudine based regimens for newborns of HIV infected mothers found ALT elevations above 3 times ULN in 14% of those receiving zidovudine alone, but none developed clinically apparent liver injury).
Agu KA, Oparah AC. (2013). Adverse drug reactions to antiretroviral therapy: Results from spontaneous reporting system in Nigeria. Perspect Clin Res. (Among 1119 adverse drug reactions reported among HIV treated subjects in Nigeria, only 2 [0.1%] were due to hepatotoxicity).
Pugi A, Bonaiuti R, Maggini V, Moschini M, Tuccori M, Leone R, Rossi M, et al. (2013). Safety profile of antiviral medications: a pharmacovigilance study using the Italian spontaneous-reporting database. Am J Health Syst Pharm. (Among 863 spontaneous reports of a drug reaction to antiviral agents over a 22 year period in Italy, 11 were due to lactic acidosis, mostly due to stavudine; zidovudine was most commonly linked to anemia).
Vispo E, Cevik M, Rockstroh JK, Barreiro P, Nelson M, Scourfield A, Boesecke C, et al., European Network of Clinical Trials (NEAT). (2013). Genetic determinants of idiopathic noncirrhotic portal hypertension in HIV-infected patients. Clin Infect Dis. (Case control study of 22 HIV infected patients with noncirrhotic portal hypertension [NCPH] and 58 controls for single nucleotide polymorphisms in genes for enzymes involved in purine metabolism identified 2 single nucleotide polymorphisms in the 5-nucleotidase and 2 in the xanthine oxidase genes associated with presence of NCPH).
Verheij J, Schouten JN, Komuta M, Nevens F, Hansen BE, Janssen HL, Roskams T. (2013). Histological features in western patients with idiopathic non-cirrhotic portal hypertension. Histopathology. (Histological analysis of 70 patients with NCPH, 13 with HIV infection who were more likely to have NRH [93% vs 46%] and who had a similar risk for underlying thrombophilic condition [31% vs 40%]).
Kupiec KE, Johnson JW, Barroso LF, Wrenn RH, Williamson JC. (2014). Zidovudine as modern day salvage therapy for HIV infection. AIDS Patient Care STDS. (In a retrospective analysis of safety and efficacy of salvage therapy including zidovudine in 69 patients with HIV infection, adverse events included nausea and diarrhea, but there were no instances of lactic acidosis or lipodystrophy).
Cooper DA, Heera J, Ive P, Botes M, Dejesus E, Burnside R, Clumeck N, et al. (2014). Efficacy and safety of maraviroc vs. efavirenz in treatment-naive patients with HIV-1: 5-year findings. AIDS. (In a 5 year follow up of studies comparing maraviroc to efavirenz combined with zidovudine and lamivudine, ALT levels greater than 5 times ULN occurred in 8 [2.2%] on maraviroc and 5 [1.4%] on efavirenz, about half of whom also had bilirubin elevations, but none of whom died of liver failure).
Sood A, Castrejón M, Saab S. (2014). Human immunodeficiency virus and nodular regenerative hyperplasia of liver: A systematic review. World J Hepatol. (A review of the literature on nodular regenerative hyperplasia in HIV infected patients).
Parikh ND, Martel-Laferriere V, Kushner T, Childs K, Vachon ML, Dronamraju D, Taylor C, et al. (2014). Clinical factors that predict noncirrhotic portal hypertension in HIV-infected patients: a proposed diagnostic algorithm. J Infect Dis. (Comparison of 35 HIV infected persons with NCPH to 68 controls identified multiple clinical differences; authors propose a diagnostic algorithm that includes exposure to didanosine, splenomegaly, low platelet count or serum enzyme elevations as suggestive of diagnosis and warranting further evaluation).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 5 of which [3%] were attributed to antiretroviral agents including nevirapine, zidovudine and lamivudine).
Yajima K, Uehira T, Otera H, Koizumi Y, Watanabe D, Kodama Y, Kuzushita N, et al. (2014). A case of non-cirrhotic portal hypertension associated with anti-retroviral therapy in a Japanese patient with human immunodeficiency virus infection. J Infect Chemother. (35 year old Japanese woman with HIV infection presented with ascites and gastrointestinal bleeding 4 years after stopping a 5 year course of didanosine [bilirubin 0.2 mg/dL, ALT 82 U/L, AST 83 U/L, Alk P 268 U/L, platelets 207,000 /µL, TE=9.3 kPa, biopsy showing no cirrhosis], with improvement and resolution of ascites and abnormal liver tests after control of bleeding and avoidance of nucleoside analogs).
Brescini L, Orsetti E, Gesuita R, Piraccini F, Marchionni E, Staffolani S, Castelli P, et al. (2014). Evaluating liver fibrosis by transient elastometry in patients with HIV-HCV coinfection and monoinfection. Hepat Mon. (Among 354 adults undergoing transient elastography (TE), abnormal stiffness was found in 13% with HIV infection alone, 39% with HCV infection alone and 51% with both; treatment with stavudine and didanosine being associated with higher TE scores).
Turon F, Silva-Junior G, Hernandez-Gea V, Garcia-Pagan JC. (2015). Hipertensión portal idiopática no cirrótica. Gastroenterol Hepatol. (Review of noncirrhotic portal hypertension including epidemiology, pathogenesis, clinical presentation and management).
Arora A, Sarin SK. (2015). Multimodality imaging of obliterative portal venopathy: what every radiologist should know. Br J Radiol. (Review of the radiologic findings of noncirrhotic portal hypertension that accompanies obliterative portal venopathy; typical findings being increased spleen size and stiffness with normal or shrunken liver, portal vein enlargement and varices).
Ioannou GN, Bryson CL, Weiss NS, Boyko EJ. (2015). Associations between lipodystrophy or antiretroviral medications and cirrhosis in patients with HIV infection or HIV/HCV coinfection. Eur J Gastroenterol Hepatol. (In an analysis of the Veterans Administration Healthcare system Clinical Care Registry, long term use of didanosine but not other antiretroviral agents was found to be a risk factor for cirrhosis in patients with HIV monotherapy in contrast to patients with HIV-HCV coinfection, in whom all long term antiretroviral therapies were risk factors for cirrhosis).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 cases [1.3%] were attributed to antiretroviral agents, including one to zidovudine and one to didanosine but none to stavudine).
Kovari H, Sabin CA, Ledergerber B, Ryom L, Reiss P, Law M, Pradier C, et al. (2016). Antiretroviral drugs and risk of chronic alanine aminotransferase elevation in human immunodeficiency virus (HIV)-monoinfected persons: the data collection on adverse events of anti-HIV drugs study. Open Forum Infect Dis. (Among 21,495 persons observed for an average of 4-5 years in a prospective observation study of adverse events among HIV positive patients without HBV or HCV on antiretroviral therapy, 6368 [30%] developed chronically elevated liver tests [6 per 100 patient years] and risk factors included didanosine, stavudine and tenofovir therapy but not lamivudine, abacavir or most protease inhibitors).
Vilarinho S, Sari S, Yilmaz G, Stiegler AL, Boggon TJ, Jain D, Akyol G, et al. (2016). Recurrent recessive mutation in deoxyguanosine kinase causes idiopathic noncirrhotic portal hypertension. Hepatology. (Complete exome sequencing of DNA from 8 children with idiopathic noncirrhotic portal hypertension identified an extremely rare gene variant which was homozygous in all 8 children, the gene being deoxyguanosine kinase, an enzyme required for mitochondrial DNA replication that is also inhibited by didanosine perhaps explaining its hepatotoxicity).
Ryom L, Lundgren JD, De Wit S, Kovari H, Reiss P, Law M, El-Sadr W, et al. (2016). D:A:D Study Group. Use of antiretroviral therapy and risk of end-stage liver disease and hepatocellular carcinoma in HIV-positive persons. AIDS. (Among 45,544 individuals followed for a median of 8.4 years in a prospective observation study of adverse events in patients with HIV infection on antiretroviral drugs, 209 developed end stage liver disease and 110 hepatocellular carcinoma, the combined rate being 1 per 1000 patient years; increase risk for these outcomes occurred in those with HCV and HBV infection but was also linked to long term therapy with stavudine, didanosine, and tenofovir).
Lee M, Izzy M, Akki A, Tanaka K, Kalia H. (2017). Nodular regenerative hyperplasia: a case of rare prognosis. J Investig Med High Impact Case Rep. (26 year old woman with perinatally acquired HIV infection developed splenomegaly and abnormal liver tests while on tenofovir, emtricitabine and atazanavir/ritonavir [bilirubin 0.7 mg/dL, ALT 83 U/L, AST 80 U/L, Alk P 260 U/L, platelets 72,000, INR 1.2, biopsy showing minimal fibrosis and nodular regeneration] who subsequently was found to have a hepatic mass on imaging suspected to be HCC; no mention of previous therapy with didanosine or stavudine).
Ahmad AK, Atzori S, Taylor-Robinson SD, Maurice JB, Cooke GS, Garvey L. (2019). Spleen stiffness measurements using point shear wave elastography detects noncirrhotic portal hypertension in human immunodeficiency virus. Medicine (Baltimore). (Among 25 patients with HIV infection undergoing shearwave elastography, spleen stiffness was more reliable than liver stiffness in assessing noncirrhotic portal hypertension, being elevated in 6 of 11 cases of NCPH but in none of 14 controls).

## OTHER REFERENCE LINKS

1 Recent References on Zidovudine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Zidovudine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Zidovudine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Zidovudine)